# Palbociclib

## OVERVIEW

### Introduction

Palbociclib is a unique cyclin-dependent kinase inhibitor that is used in combination with aromatase inhibitors in the treatment of postmenopausal women with metastatic breast cancer. Palbociclib is associated with transient and usually mild elevations in serum aminotransferase during therapy and to an unusual form of liver injury called pseudocirrhosis caused by shrinkage of tumor metastases in the liver combined with desmoplastic changes and vascular damage, that can be severe, progressive and even fatal.

### Background

Palbociclib (pal" boe sye' klib) is an orally available, specific inhibitor of cyclin-dependent kinases that is used in combination with aromatase inhibitors in the therapy of postmenopausal women with metastatic breast cancer that is positive for the estrogen receptor (ER+), but negative for human epidermal growth factor receptor 2 (HER2-). The cyclin kinases 4 and 6 regulate the cellular transition from the G1 to the S phase of the cell cycle. Inhibition of this transition blocks the progression of the cell cycle and results in growth arrest in rapidly dividing cells. The addition of palbociclib to letrozole or fulvestrant (aromatase inhibitors) therapy of metastatic breast cancer (ER+, HER2-) in postmenopausal women was associated with a prolongation of disease free survival. Palbociclib received accelerated approval for use in the United States in 2015, and it is still under close evaluation for its long term safety and efficacy. Palbociclib is available in capsules of 75, 100 and 125 mg and the typical maintenance dose is 125 mg once daily in 21 day cycles every 28 days indefinitely or until there is disease progression. Common side effects include fatigue, nausea, diarrhea, anorexia, neutropenia, fever, anemia, thrombocytopenia, epistasis, peripheral neuropathy and pulmonary embolism. Severe adverse events include neutropenic fever and sepsis.

### Hepatotoxicity

In the large clinical trials, adverse events were common and led to dose reductions in one-third of patients and discontinuation in 8%. Publications on the efficacy and safety of palbociclib rarely mentioned serum ALT elevations or hepatotoxicity. In a study of women with refractory, metastatic breast cancer, serum ALT elevations occurred in 6% [2% over 5 times ULN] receiving palbociclib and fulvestrant compared to 3% [none over 5 times ULN] on fulvestrant alone. Since its approval and more widescale use, there have been several reports of prominent ALT elevations arising after 2 or 3 cycles of palbociclib, that improved on discontinuation and recurred rapidly when restarted. Serum bilirubin and alkaline phosphatase levels were normal and symptoms were not mentioned. In addition, there have been rare reports of patients with refractory metastatic breast cancer who developed pseudocirrhosis within 2 to 3 months of starting palbociclib presenting with fatigue, jaundice and ascites with only modest elevations in serum aminotransferase and alkaline phosphatase levels. Imaging revealed a severely nodular liver, but liver histology showed desmoplastic changes in areas of necrotic metastatic tumor without cirrhosis. The liver also had vascular changes suggestive of sinusoidal obstruction syndrome, changes possibly caused by the dramatic involution of the metastatic tumor tissue combined with vascular damage. Pseudocirrhosis has been reported with other highly successful antineoplastic therapies of cancer metastatic to the liver, but the frequency is rare.

Likelihood score: C (probable rare cause of clinically apparent liver injury that may represent pseudocirrhosis from nodular transformation of the liver in response to necrosis of hepatic metastases).

### Mechanism of Injury

The possible causes of serum enzyme elevations or liver injury from palbociclib therapy are not known. Palbociclib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury might be caused by production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, palbociclib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity. Pseudocirrhosis due to palbociclib is thought to be due to the necrosis and involution of hepatic metastases that cause an altered hepatic architecture and vasculature resulting in liver dysfunction.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between palbociclib and other cyclin dependent kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Cyclin-Dependent Kinase Inhibitor Drugs: Ribociclib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Palbociclib – Ibrance®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Palbociclib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Palbociclib | 571190-30-2 | C24-H29-N7-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2020

Abbreviations: ER, estrogen receptor; HER2, human epidermal growth factor receptor 2.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as palbociclib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not palbociclib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; palbociclib is not discussed).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of palbociclib which is not discussed).
Dickson MA, Tap WD, Keohan ML, D'Angelo SP, Gounder MM, Antonescu CR, Landa J, et al. (2013). Phase II trial of the CDK4 inhibitor PD0332991 in patients with advanced CDK4-amplified well-differentiated or dedifferentiated liposarcoma. J Clin Oncol. (Among 30 patients with liposarcoma treated with palbociclib adverse events included neutropenia [50%], thrombocytopenia [30%] and anemia [17%], with no mention of ALT elevations or hepatotoxicity).
Vaughn DJ, Hwang WT, Lal P, Rosen MA, Gallagher M, O'Dwyer PJ. (2015). Phase 2 trial of the cyclin-dependent kinase 4/6 inhibitor palbociclib in patients with retinoblastoma protein-expressing germ cell tumors. Cancer. (Among 30 patients with germ cell tumors treated with palbociclib, response rates were poor and toxicities were largely hematologic; no mention of ALT elevations or hepatotoxicity).
Beaver JA, Amiri-Kordestani L, Charlab R, Chen W, Palmby T, Tilley A, Zirkelbach JF, et al. (2015). FDA Approval: Palbociclib for the treatment of postmenopausal patients with estrogen receptor-positive, HER2-negative metastatic breast cancer. Clin Cancer Res. (Review of the studies of clinical efficacy and safety that led to the FDA approval of palbociclib; mentions that adverse events were common and led to dose reduction in 36% and discontinuation in 8% of patients; no mention of ALT elevations or hepatotoxicity).
Mangini NS, Wesolowski R, Ramaswamy B, Lustberg MB, Berger MJ. (2015). Palbociclib: a novel cyclin-dependent kinase inhibitor for hormone receptor-positive advanced breast cancer. Ann Pharmacother. (Review of the structure, mechanism of action, pharmacology, clinical efficacy and safety of palbociclib as therapy of metastatic breast cancer, discusses neutropenia and infections but does not mention ALT elevations or hepatotoxicity).
Finn RS, Crown JP, Lang I, Boer K, Bondarenko IM, Kulyk SO, Ettl J, et al. (2015). The cyclin-dependent kinase 4/6 inhibitor palbociclib in combination with letrozole versus letrozole alone as first-line treatment of oestrogen receptor-positive, HER2-negative, advanced breast cancer (PALOMA-1/TRIO-18): a randomised phase 2 study. Lancet Oncol. (Among 165 women with metastatic breast cancer [ER+, HER2-] treated with letrozole with or without palbociclib for an average of 28 months, progression-free survival was longed with palbociclib, but side effects including neutropenia were more frequent and severe; no mention of ALT elevations or hepatotoxicity).
Turner NC, Ro J, André F, Loi S, Verma S, Iwata H, Harbeck N, et al., PALOMA3 Study Group. (2015). Palbociclib in Hormone-Receptor-Positive Advanced Breast Cancer. N Engl J Med. (Among 521 women with advanced breast cancer [ER+, HER2-] treated with letrozole and either palbociclib or placebo for up to 1 year, progression-free survival was prolonged by adding palbociclib [9.2 vs 3.8 months] and side effects were more common including neutropenia [62% vs 1%] and fatigue [38% vs 26%]; no mention of ALT elevations or hepatotoxicity).
DeMichele A, Clark AS, Tan KS, Heitjan DF, Gramlich K, Gallagher M, Lal P, et al. (2015). CDK 4/6 inhibitor palbociclib (PD0332991) in Rb+ advanced breast cancer: phase II activity, safety, and predictive biomarker assessment. Clin Cancer Res. (Among 37 women with metastatic breast cancer [ER+, HER2-] treated with palbociclib, adverse events [largely hematologic] were common, but rarely led to dose interruption; no mention of ALT elevations or hepatotoxicity).
(2015). Palbociclib (Ibrance) for metastatic breast cancer. Med Lett Drugs Ther. (Concise review of efficacy and safety of palbociclib as therapy for metastatic breast cancer, mentions frequency of severe neutropenia and risk of septicemia; no mention of hepatotoxicity or ALT elevations).
Cristofanilli M, Turner NC, Bondarenko I, Ro J, Im SA, Masuda N, Colleoni M, et al. (2016). Fulvestrant plus palbociclib versus fulvestrant plus placebo for treatment of hormone-receptor-positive, HER2-negative metastatic breast cancer that progressed on previous endocrine therapy (PALOMA-3): final analysis of the multicentre, double-blind, phase 3 randomised controlled trial. Lancet Oncol. (Among 521 women with refractory, metastatic ER+, HER2- breast cancer treated with fulvestrant with or without palbociclib, progression-free survival was improved with palbociclib therapy [9.5 vs 4.6 months] but adverse events were more frequent including neutropenia [65% vs 1%], while ALT elevations arose in 6% vs 3% and were above 5 times ULN in 2% vs 0%]).
Finn RS, Martin M, Rugo HS, Jones S, Im SA, Gelmon K, Harbeck N, et al. (2016). Palbociclib and letrozole in advanced breast cancer. N Engl J Med. (Among 666 women with previously untreated, ER+, HER2- metastatic breast cancer treated with letrozole with or without palbociclib, the median progression-free survival was greater with palbociclib [24.8 vs 14.5 months], but neutropenia was common [66% vs 1%], no mention of ALT elevations or hepatotoxicity).
Vuppalanchi R, Saxena R, Storniolo AMV, Chalasani N. (2017). Pseudocirrhosis and liver failure in patients with metastatic breast cancer after treatment with palbociclib. Hepatology. (Two women, ages 47 and 61 years with refractory metastatic breast cancer developed fatigue, jaundice and ascites after 3 and 2 cycles of palbociclib [bilirubin 11.7 and 2.6 mg/dL rising to 34 and 10 mg/dL, ALT 59 and 53 U/L, Alk P 128 and 243 U/L], imaging studies showing a nodular liver and ascites but liver histology showing pseudocirrhosis and possibly sinusoidal obstruction syndrome, both patients dying of hepatic failure).
Roberts BA, Ibrahim M, Stone E. (2018). Elevated liver function tests in a patient on palbociclib and fulvestrant. J Community Support Oncol. (57 year old woman with metastatic breast cancer developed abnormal liver tests after 3 monthly cycles of palbociclib and fulvestrant [ALT 446 U/L, bilirubin and Alk P normal], which resolved within 4-6 weeks despite restarting fulvestrant but then recurred within 10 days of restarting palbociclib [ALT 285 U/L]).
Ettl J. (2019). Management of adverse events due to cyclin-dependent kinase 4/6 inhibitors. Breast Care (Basel). (Overview recommendations on management of adverse events associated with cyclin-dependent kinase 4/5 inhibitors focusing upon neutropenia, mentions that monitoring of routine liver tests is recommended on days 1 and 14 of the first 2 cycles of therapy and on day 1 of subsequent courses, but that ALT elevations are more frequent with ribociclib and abemaciclib than with palbociclib, and there does not appear to be cross sensitivity to the hepatic adverse effects).
Farhat F, Tarabaih M, Kanj A, Aoun M, Kattan J, Assi T, Awada A. (2020). Palbociclib safety and efficacy beyond ribociclib-induced liver toxicity in metastatic hormone-receptors positive breast cancer patient. Anticancer Drugs. (55 year old woman with metastatic breast cancer had a clinical response to ribociclib therapy but after 3 months developed ALT elevations [424 U/L], which improved on stopping but rose again upon restarting (ALT 613 U/L), yet later tolerated palbociclib therapy and maintained normal ALT levels).
Atallah R, Parker NA, Hamouche K, Truong QV, Dingwall M. (2020). Palbociclib-induced liver failure. Kans J Med. (79 year old woman with metastatic breast cancer was found to have abnormal liver tests after a second course of palbociclib and fulvestrant [bilirubin 4.6 rising to 9.8 mg/dL, ALT 50 U/L, Alk P 150 U/L, INR 3.8], with E. coli septicemia and progressive multiorgan failure and death).

## OTHER REFERENCE LINKS

1 Recent References on Palbociclib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Palbociclib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Palbociclib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Palbociclib)